# Energy Drinks

## OVERVIEW

### Introduction

Energy drinks are defined as over-the-counter commercial beverages with high caffeine content that are advertised as boosting energy including mental alertness and physical performance. More than 50 brands of energy drinks are available in grocery stores, nutrition centers, beverage shops and on the internet. Consumption of excess energy drinks has been linked to several instances of clinically apparent acute liver injury which can be severe and result in fatal or urgent liver transplantation. The components in energy drinks that account for the liver injury are not clear and caffeine by itself has not been linked to hepatic injury.

### Background

Energy drinks are defined as beverages with high concentrations of caffeine that are purported to boost energy, physical and athletic performance and mental alertness. Energy drinks were first marketed in the late 1990s and have subsequently become popular and widely available. The commercial products vary greatly in concentration of caffeine as well as in other characteristics, such as carbonation, flavoring, sugar and sweeteners, vitamins, minerals, amino acids and botanical ingredients. Popular brands include Red Bull, Monster, Rockstar, NOS Energy, Xyience, Bang, Celsius, Zevia, Full Throttle and Kick Start. The caffeine content of these products varies from 5 to 40 mg per ounce, and a single serving (8 to 24 ounces; 235-710 mL) may contain up to 300 mg of caffeine. Caffeine is also present in regular soft drinks but generally in amounts similar to tea (2 to 5 mg/oz; and 24 to 60 mg per 12 oz can), although soft drink brands with extra caffeine have also become popular (Pepsi Max, Jolt Cola, Mountain Dew Energy). The average caffeine content in selected energy drinks and soft drinks is shown in the table below. Caffeine has been shown to have psychoactive properties and to increase alertness and wakefulness and improve physical and athletic performance, although to a minor degree and with considerable inter-individual variability. Caffeine in typical amounts is well tolerated and not associated with significant side effects or long term adverse outcomes. Adverse side effects of caffeine are generally dose related and can include nervousness, irritability, insomnia, headaches, rapid heartbeat, tremor, and gastrointestinal discomfort. In high doses, generally in excess of 1000 mg daily, caffeine can have severe toxicity, marked by confusion, excessive anxiety, mania, hallucinations, seizures, rhabdomyolysis, cardiorespiratory arrest and death.

Caffeine Content of Selected Soft Drinks and Energy Drinks Available in the United States

Product Name | Caffeine (mg/oz) | Typical size (Can/Bottle) | Caffeine (mg/Serving) | Comments, Selected Other Ingredients
Soft Drinks
Coca-Cola | 2.9 | 12 oz | 23
Pepsi | 3.2 | 12 oz | 38
Dr Pepper | 3.4 | 12 oz | 41
Mountain Dew | 4.5 | 12 oz | 54
Diet Pepsi | 2.9 | 12 oz | 35
Diet Dr Pepper | 3.4 | 12 oz | 41
Diet Coke | 3.8 | 12 oz | 46
Diet Mountain Dew | 4.5 | 12 oz | 54
Sprite | 0 | 12 oz | 0
7-Up | 0 | 12 oz | 0
Fortified Soft Drinks
Pepsi Max | 3.8 | 8 oz | 43
Mountain Dew Kickstart | 5.8 | 16 oz | 92
Coca-Cola Energy | 9.5 | 12 oz | 114
AMP Energy | 9 | 16 oz | 142
Energy Drinks
Red Bull | 10 | 8 oz | 80 | Most commonly used energy drink
V8 Fusion | 10 | 8 oz | 80 | 50% vegetable juice
Zevia | 10 | 12 oz | 120 | Stevia as sweetener, calorie-less
Rockstar | 10 | 16 oz | 160 | Taurine, ginseng, ginkgo, milk thistle
NOS | 10 | 16 oz | 160 | Taurine, acacia, B vit
Jolt Cola | 10 | 16 oz | 160
Xyience | 11 | 16 oz | 176 | Ginseng, Guarana, vit, aa, min
Celsius | 12 | 16 oz | 200 | Green tea, guarana, ginger, vit, min
5-Hour Energy | 100 | 2 oz | 200 | Vit, aa
Spike Shooter | 36 | 8 oz | 300 | Yohimbine, vit, aa “Spike S formula”
Redline Xtreme | 40 | 8 oz | 316 | Green tea, yohimbe, yerba mate, aa
Other
Typical Drip Coffee | 8-20 | 1 cup, 8 oz | 60-150
Typical Black Tea | 2 to 5 | 1 cup, 8 oz | 15-35

* Concentrations and volumes are rounded off. Several of the commercial products have multiple formulations, flavors and special names. Abbreviations: aa, amino acids; min, minerals; vit, vitamins.

### Hepatotoxicity

Caffeine containing energy drinks are widely used and generally well tolerated. Neverless, when taken in excessive amounts they can lead to caffeine toxicity with tremors, confusion, mania, stupor and coma and cardiac arrhythmias and cardiorespiratory failure. In addition, there have been several single case reports of liver injury linked to use of caffeine-rich energy drinks. These reports were often incompletely documented and not completely convincing. In several instances, the hepatic injury resembled acute hepatic necrosis or ischemic hepatitis (Case 1) that may have been due to a drug overdose or cardiac arrest. In other cases, other diagnoses were not completely ruled out (Case 2). Furthermore, it remains unclear whether the hepatic effects of the energy drinks were caused by caffeine per se or to other components included in their formulation, such as vitamins, herbs or other botanical products. The reports of caffeine overdose including cases with autopsies, hepatic injury has been absent or not mentioned. Thus, caffeine is unlikely to cause liver injury, but the various high caffeine energy drinks which are widely used may possibly cause liver injury when used to excess.

Likelihood score: C[H] (probable rare cause of clinically apparent liver injury when used in high amounts).

### Mechanism of Injury

Caffeine is metabolized by the microsomal P450 drug metabolizing enzymes, predominantly CYP 1A2. Patients with advanced cirrhosis may have delayed metabolism of caffeine and experience caffeine side effects (nervousness, insomnia, headache) at levels of intake that are well tolerated by patients without liver disease.

Energy drinks typically have high concentrations of caffeine but also a myriad of other components including vitamins, minerals, amino acids, sugar and various herbal products, the concentration and purity of which are usually unknown.

Drug Class: CNS Stimulants, Xanthine Derivatives

See also Caffeine

## CASE REPORT

### Case 1. Acute liver injury attributed to use of energy drinks.(1)

A 22 year old woman developed low grade fever, abdominal pain, nausea and vomiting and was found to have abnormal liver tests after having consumed 10 cans of energy drinks daily for 2 weeks. On examination in the emergency room, she had epigastric tenderness but no other findings and was sent home. The following day she developed jaundice and was admitted to the hospital. She denied alcohol or drug abuse and was not taking other medications. Laboratory tests showed marked elevations in ALT and AST (Table) but normal levels of bilirubin, alkaline phosphatase and GGT. The INR was 1.6. Acetaminophen levels were undetectable. There was no serologic evidence of acute hepatis A, B, C or E and tests for Epstein Barr virus and cytomegalovirus infection were negative. She was managed conservatively. She did not undergo liver biopsy or imaging studies. Serum aminotransferase levels decreased rapidly and she was discharged four days later. In follow up one month later, she was asymptomatic and serum ALT levels were normal.

#### Key Points

Medication: | Energy drinks (10 cans daily for 2 weeks)
Pattern: | Hepatocellular (R=~172)
Severity: | 3+ (jaundice and Hospitalization)
Latency: | 2 weeks
Recovery: | Within 1 month
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
2 weeks | 0 | 216 | 171 | | 1.7 | Nausea, abdominal pain
| 1 day | 7533 | 7709 | Normal | 3.5 | GGT 29, INR 1.6
| 5 days | 1947 | 238 | | 1.7 | Discharged
| 1 month | 22 | 26
Normal Values | | Not given | | | <1.2

#### Comment

This short report described a young woman who presented with acute hepatic necrosis that was attributed to consumption of energy drinks for two weeks. The marked ALT and AST levels, the R ratio above 100, the abnormality of INR with minimal elevation in bilirubin and the rapid improvement within a week of onset are typical features of acute hepatic necrosis and not typical of the acute hepatitis seen with idiosyncratic drug induced liver injury. The clinical presentation was similar to that of acute acetaminophen overdose or acute ischemic hepatitis, both of which might be considered more likely than acute injury from a commercial energy drink. The components of the energy drink that were responsible for the severe acute liver injury were not clear. The product name of the energy drink was not provided, but the ingredients listed in the report included vitamins, minerals and an “energy blend” which was likely to include caffeine, but other herbal components were not given.

### Case 2. Acute hepatitis attributed to use of energy drinks.(2)

A 50 year old previously healthy man developed nausea, anorexia, epigastric pain and fatigue followed by dark urine and jaundice and was found to have markedly abnormal liver tests. He reported that he had been drinking 4 to 5 cans of an energy drink for the previous 3 weeks. He denied a history of liver disease, drug allergies, alcohol abuse, injection drug use or risk factors for viral hepatitis. He was not taking other medications or over-the-counter products. Initially, total serum bilirubin was 10.3 mg/dL (direct 7.7), ALT 1203 U/L, AST 1802 U/L, alkaline phosphatase 206 U/L, and INR 1.0. Tests for acute hepatitis A, B and E were negative, but he was positive for both anti-HCV and HCV RNA (5.6 million IU/mL). Antinuclear and smooth muscle antibodies were negative. Ultrasound of the abdomen showed no gallstones or evidence of biliary obstruction. A liver biopsy showed acute hepatitis with bridging necrosis and cholestasis but no fibrosis. Despite the HCV serology, he was diagnosed as having liver injury due to consumption of energy drinks, the suspected ingredient being niacin. After worsening for a few days, he began to improve spontaneously (Table) and in follow up weeks later he was asymptomatic and serum aminotransferase levels were normal. Follow up HCV RNA results were not reported.

#### Key Points

Medication: | Energy drinks (4-5 cans daily for 3 weeks)
Pattern: | Hepatocellular (R=~18.8)
Severity: | 3+ (jaundice and Hospitalization)
Latency: | 3 weeks
Recovery: | Unclear in timing
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 weeks | 1 day | 1203 | 1802 | 206 | 10.3 | Hospitalized
| 2 days | 1112 | 1710 | | 11.5 | Anti-HCV and HCV RNA positive
| 3 days | 1368 | 2435 | | 13.4 | Liver biopsy
| 4 days | 2073 | 4051 | | 19.3
| 5 days | 1629 | 2674 | | 15.7
| 6 days | 1224 | 1695 | | 12.0 | Discharged, asymptomatic
5 weeks | 14 days | 90 | 35 | | 2.7
| 18 days | 23 | 36 | | 2.2
Normal Values | | <38 | <42 | <130 | <1.2

#### Comment

This case report described a 50 year old construction worker who presented with acute hepatitis three weeks after starting regular consumption of energy drinks (4 to 5 cans of an undeclared product daily). Importantly, he also tested positive for anti-HCV and HCV RNA despite having no risk factors for hepatitis C and no previous knowledge of being infected. The authors attributed the acute hepatitis to consumption of the energy drinks and not to hepatitis C, arguing that he more likely had an asymptomatic chronic HCV infection. However, the clinical presentation, liver biopsy findings and subsequent course are entirely compatible with acute hepatitis C. The challenge in this diagnosis is that serologic tests (including IgM anti-HCV) are unreliable in separating acute from chronic infection, and definitive diagnosis of acute vs chronic HCV infection depends upon documentation of seroconversion to anti-HCV positivity. The diagnosis can also be fairly reliably made if the infection resolves as the hepatitis resolves with disappearance of HCV RNA (and rising titers of anti-HCV) or if there is a recent clear history of exposure. Such documentation, however, is not always available and a high proportion of patients with acute hepatitis C develop de novo chronic infection. In large case series, acute hepatitis C accounts for 1% to 5% of cases initially suspected to be drug induced liver injury. Of the six reported cases of acute liver injury from energy drink consumption published between 2000 and 2020, none were very convincing and most had other possible explanations (ischemic hepatitis, liver injury from other drugs being taken, acetaminophen or other toxic overdose).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Energy Drinks – Monster®, NOS®, Red Bull®, Rockstar®

DRUG CLASS

CNS Stimulants, Xanthine Derivatives

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?query=Caffeine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Caffeine | 58-08-2 | C8-H10-N4-O2

## CITED REFERENCES

1 Vivekanandarajah A, Ni S, Waked A. (2011). Acute hepatitis in a woman following excessive ingestion of an energy drink: a case report. J Med Case Rep.
2 Harb JN, Taylor ZA, Khullar V, Sattari M. (2016). Rare cause of acute hepatitis: a common energy drink. BMJ Case Rep.

## ANNOTATED BIBLIOGRAPHY

References updated: 18 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; caffeine and energy drinks are not discussed).
Caffeine Informer. https://www.caffeineinformer.com/the-caffeine-database (Website on caffeine that provides information on the sources of caffeine, its clinical effects and side effects and a database on the caffeine content of coffees, teas, candy, foods, soft drinks and energy drinks).
O’Brien CP. Caffeine. In, Drug use disorders and addiction . In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 440. (Textbook of pharmacology and therapeutics).
Winek CL, Wahba W, Williams K, Blenko J, Janssen J. (1985). Caffeine fatality: a case report. Forensic Sci Int. (21 year old woman took an overdose of 70 tablets that she thought were amobarbital but actually were mostly caffeine, and had a fatal cardiorespiratory arrest, autopsy demonstrating caffeine blood levels of 240 mg/L).
Zimmerman PM, Pulliam J, Schwengels J, MacDonald SE. (1985). Caffeine intoxication: a near fatality. Ann Emerg Med. (37 year old woman took an overdose of 27 gm of caffeine and rapidly developed hypotension, tachycardia, confusion, acidosis and coma [pH 7.2] followed by repeated episodes of ventricular fibrillation treated successfully with dialysis and medical support [initial caffeine level 199 mg/L], allowing for discharge 27 days later).
Cannon ME, Cooke CT, McCarthy JS. (2001). Caffeine-induced cardiac arrhythmia: an unrecognised danger of healthfood products. Med J Aust. (25 year old woman with known mitral value prolapse had a fatal, witnessed cardiac arrest [ventricular fibrillation] having just consumed a large bottle of an energy drink [Race 2005: 300-570 mg of caffeine]; no mention of hepatic abnormalities).
Holmgren P, Nordén-Pettersson L, Ahlner J. (2004). Caffeine fatalities--four case reports. Forensic Sci Int. (4 patients with fatal caffeine overdoses with lethal levels of caffeine in postmortem blood tests; no description of hepatic effects, although three had known risk factors for liver disease [alcoholism, drug abuse, hepatitis C]).
Kerrigan S, Lindsey T. (2005). Fatal caffeine overdose: two case reports. Forensic Sci Int. (Two patients with fatal caffeine overdose, 39 year old woman with known drug use found dead and 29 year old male with obesity, diabetes and known overdose with caffeine pills and vomiting and seizures, had postmortem blood caffeine levels of 192 and 567 mg/L; no mention of liver abnormalities).
Iyadurai SJ, Chung SS. (2007). New-onset seizures in adults: possible association with consumption of popular energy drinks. Epilepsy Behav. (Four adults had new onset seizures accompanied by transient tachycardia and hypertension shortly after consuming energy drinks [Rockstar, Monster], usually on an empty stomach or with diet pills and not recurring during follow up when the energy drinks were stopped; all four had no “laboratory abnormalities” except for high glucose in one).
Haller C, Kearney T, Bent S, Ko R, Benowitz N, Olson K. (2008). Dietary supplement adverse events: report of a one-year poison center surveillance project. J Med Toxicol. (Among 275 poison control center calls about dietary supplements occurring over a 12 month period, 112 [41%] were symptomatic, 8 resulted in hospitalization and one was fatal, the majority of symptomatic cases [47%] were related to a caffeine-containing multiingredient products; no mention of hepatotoxicity).
Berger AJ, Alford K. (2009). Cardiac arrest in a young man following excess consumption of caffeinated "energy drinks". Med J Aust. (28 year old man had cardiac arrest [ventricular fibrillation] shortly after consuming 7-8 cans of an energy drink [~640 mg of caffeine] and underwent extensive evaluation including coronary angiography which was normal; no mention of liver test abnormalities).
Higgins JP, Tuttle TD, Higgins CL. (2010). Energy beverages: content and safety. Mayo Clin Proc. (Review of the increasing popularity of energy drinks which often have high levels of caffeine [50-505 mg/serving] but are not regulated in regard to caffeine concentration or claims for performance enhancement; other ingredients may include glucose, taurine, branched chain amino acids, various vitamins, ginseng, guarana, ginkgo, milk thistle, L-carnitine and citric acid).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 12 [9%] attributed to herbals, but none to energy drinks).
Vivekanandarajah A, Ni S, Waked A. (2011). Acute hepatitis in a woman following excessive ingestion of an energy drink: a case report. J Med Case Rep. (22 year old woman developed abdominal pain, nausea and vomiting having consumed 10 cans of energy drinks daily for 2 weeks [bilirubin 1.7 rising to 3.5 mg/dL, ALT 216 rising to 7553 U/L, Alk P and GGT normal, INR 1.6], recovering within the next few weeks with no specific therapy: Case 1).
Apestegui CA, Julliard O, Ciccarelli O, Duc DK, Lerut J. (2011). Energy drinks: another red flag for the liver allograft. Liver Transpl. (16 year old man with liver transplant developed sudden rise in liver tests on two occasions one year apart after consuming 3-5 cans of Red Bull daily [ALT 6 and 26 times ULN, bilirubin peak of 2.3 and 10.7 mg/dL], resolving in 4 to 8 months).
Trabulo D, Marques S, Pedroso E. (2011). Caffeinated energy drink intoxication. BMJ Case Rep. (28 year old man had sudden onset of seizures followed by lactic acidosis, coma and respiratory arrest shortly after drinking several cans of an energy drink [Red Bull] together with coffee, recovering within a week with medical support; no mention of liver test abnormalities although he had a history of injection drug use and hepatitis C).
Babu KM, Zuckerman MD, Cherkes JK, Hack JB. (2011). First-onset seizure after use of an energy drink. Pediatr Emerg Care. (15 year old adolescent boy developed seizures after drinking 2 bottles of “5-hour ENERGY” with emesis and tachycardia [caffeine level 99 mg/L]; he had no further seizures in follow up without anticonvulsant therapy).
Calabrò RS, Italiano D, Gervasi G, Bramanti P. (2012). Single tonic-clonic seizure after energy drink abuse. Epilepsy Behav. (20 year old man had a single seizure having consumed 4-6 cans of Red Bull daily for 5 months and had no further seizures in follow up after stopping energy drink consumption).
Wolk BJ, Ganetsky M, Babu KM. (2012). Toxicity of energy drinks. Curr Opin Pediatr. (Review of the literature on adverse events linked to consumption of energy drinks including cardiovascular [arrhythmias, sudden death], renal [acute renal failure], hepatic [acute hepatitis], neurologic [seizures] and psychiatric effects [anxiety, poor sleep, developmental problems], the ingredients responsible for the adverse events not always being attributable to caffeine).
Sepkowitz KA. (2013). Energy drinks and caffeine-related adverse effects. JAMA. (History of FDA actions in limiting and regulating caffeine containing products, including warning letters concerning energy drinks, mentions that many products do not list the concentration of caffeine and that there may be great individual variation in sensitivity or pharmacodynamics of caffeine which can be affected by underlying liver disease, alcohol use and medications that are metabolized via CYP 1A2).
Noff T, Insel J. (2013). Energy drinks and the unwanted buzz: a case report. Md Med. (46 year old woman with coronary artery disease developed severe chest pain having consumed 3-5 energy drinks daily for 6 months and was found to have abnormal serum aminotransferase levels [bilirubin normal, ALT 325 U/L, AST 437 U/L] which the authors attributed to niacin [30 mg per serving] in the energy drinks; no further details provided).
Consumption of Caffeine in Food and Dietary Supplements; Food and Nutrition Board; Board on Health Sciences Policy; Institute of Medicine. Caffeine in Food and Dietary Supplements: Examining Safety: Workshop Summary. Washington (DC): National Academies Press (US); 2014 Apr 23. (Summary of a workshop on the consumption of caffeine in the United States and evidence for and against cardiovascular and central nervous system safety; no discussion of liver toxicity).
Huang B, Kunkel D, Kabany ME. (2014). Acute liver failure following one year of daily consumption of a sugar-free energy drink. ACG Case Rep J. (36 year old man developed jaundice having consumed 3 energy drinks [Rockstar] daily for a year and having a 15 year history of binge alcohol drinking [bilirubin 16.1 mg/dL, ALT 2995 U/L, Alk P 231 U/L, INR 1.0], with subsequent worsening [bilirubin rising to 23.1 mg/dL, INR 3.7, hepatic encephalopathy], ultimately requiring and undergoing a successful liver transplantation).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, one case was attributed to an energy drink [Celsius Fruit Drink] that also contains green tea extract).
Eichner ER. (2014). Fatal caffeine overdose and other risks from dietary supplements. Curr Sports Med Rep. (Editorial on the dangers including fatalities of unregulated dietary supplements that may contain excessive amounts of caffeine or have toxicities due to contaminants such as amphetamines [Frenzy, Craze] or aegeline [OxyELITE Pro]).
Gurley BJ, Steelman SC, Thomas SL. (2015). Multi-ingredient, caffeine-containing dietary supplements: history, safety, and efficacy. Clin Ther. (Extensive review of the history, clinical efficacy and safety of multiingredient, caffeine containing dietary supplements which have been widely used as stimulants and weight loss agents and may have greater cardiovascular and neurologic adverse effects because of increase in caffeine toxicity caused by interaction with other components in the supplements such as taurine, p-synephrine, yohimbine, green tea, theanine, dimethylamylamine [DMAA], diethylphenylethylamine [DEPEA] and, previously, ephedra).
Harb JN, Taylor ZA, Khullar V, Sattari M. (2016). Rare cause of acute hepatitis: a common energy drink. BMJ Case Rep. (50 year old man developed an acute hepatitis 3 weeks after consuming 4-5 energy drinks daily [bilirubin 10.3 rising to 19.3 mg/dL, ALT 1203 U/L, Alk P 206 U/L, anti-HCV and HCV RNA positive], with rapid resolution on stopping the energy drinks but no information on HCV RNA levels in follow up: Case 2).
Temple JL, Bernard C, Lipshultz SE, Czachor JD, Westphal JA, Mestre MA. (2017). The safety of ingested caffeine: a comprehensive review. Front Psychiatry. (Review of the safety of caffeine for healthy as well as vulnerable populations concludes that daily intake of up to 400 mg of caffeine is probably safe for healthy adults, but lower levels should be recommended for children and pregnant women).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists published cases for multiple agents, but energy drinks are not discussed).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, of which 5 were attributed to OxyELITE Pro, but none to caffeine or energy drinks).
Higgins JP, Babu K, Deuster PA, Shearer J. (2018). Energy drinks: a contemporary issues paper. Curr Sports Med Rep. (Review of the definition, efficacy and safety of energy drinks which have become increasingly popular, particular among high school and college students, athletes and body builders, and are defined as high caffeine containing beverages that usually contain miscellaneous other components such as vitamins, minerals, amino acids and herbal products such as ginseng, yohimbe and ginkgo; adverse effects are largely attributable to caffeine and include neurologic and cardiovascular effects, with only rare, isolated reports of liver or kidney injury).
Harty PS, Zabriskie HA, Erickson JL, Molling PE, Kerksick CM, Jagim AR. (2018). Multi-ingredient pre-workout supplements, safety implications, and performance outcomes: a brief review. J Int Soc Sports Nutr. (Review of the efficacy and safety of multiingredient pre-workout supplements which typically contain caffeine, amino acids, nitrates and creatine and are “relatively safe with minimal reported adverse events”, mentions that their use has not been linked to serum enzyme elevations; no discussion of hepatotoxicity or concurrent use of anabolic steroids).
Al Yacoub R, Luczkiewicz D, Kerr C. (2020). Acute kidney injury and hepatitis associated with energy drink consumption: a case report. J Med Case Rep. (62 year old woman with advanced small cell lung cancer in hospice developed nausea, vomiting and confusion and was found to have abnormal liver tests [bilirubin 0.3 mg/dL, ALT 2866 U/L, AST 4333 U/L, Alk P 111 U/L], having had little oral intake for 2 weeks except for 5-6 cans of an energy drink daily).

## OTHER REFERENCE LINKS

1 Recent References on Energy Drinks: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Caffeine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Energy Drinks: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Caffeine)